# Peramivir

## OVERVIEW

### Introduction

Peramivir is an inhibitor of the influenza neuraminidase enzyme and is used as therapy of acute symptomatic influenza A and B. Peramivir has not been associated with serum enzyme elevations during therapy or with clinically apparent liver injury.

### Background

Peramivir (per am' i vir) is a sialic acid analog and potent inhibitor of the virus-encoded neuraminidases of influenza A and B. In several prospective clinical trials, peramivir given as a single intravenous infusion [300 to 600 mg] within 2 days of symptomatic onset, shortened the period of symptoms and viral shedding. Peramivir was approved in the United States under an emergency use authorization during the influenza A (H1N1) epidemic in 2009 and received standard full approval in 2014. Current formal indications are for the treatment of acute, uncomplicated influenza A or B in adults or children above the age of 2 years who have been symptomatic for 2 days or less. It is not approved for, but is widely used in, patients with complicated, life-threatening influenza. Peramivir is used only for treatment of influenza and is not indicated for prophylaxis after a known exposure. Peramivir is available in single use vials of 200 mg in 20 mL [10 mg/mL] under the brand name Rapivab. The recommended dose in adults is a single intravenous infusion of 600 mg administered over 15 to 30 minutes. Side effects from peramivir infusions are uncommon and generally mild, including headache, nausea and vomiting. Rare, but potentially severe adverse events include hypersensitivity reactions, anaphylaxis, Stevens Johnson syndrome and acute delirium and hallucination. Recommendations for treatment and prophylaxis of influenza in the United States change frequently in response to changes in the circulating influenza strains and antiviral resistance patterns. Regularly updated recommendations are available from the Centers for Disease Control and Prevention at: https://www.cdc.gov/flu/.

### Hepatotoxicity

Despite widespread use, there is little evidence that peramivir, when given as recommended as a single intravenous infusion, is associated with liver injury, either in the form of serum enzyme elevations or clinically apparent liver disease. A proportion of patients with influenza may have minor serum enzyme elevations during the acute illness, but these appear to be independent of therapy and are not exacerbated by peramivir.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which peramivir might cause liver injury is unknown. Peramivir is not significantly metabolized in humans and 90% is excreted unchanged in the urine. Peramivir is not a substrate for the cytochrome P450 enzyme system and demonstrates no significant drug-drug interactions. Peramivir is typically given as a single intravenous infusion, and the brief exposure and minimal hepatic metabolism may account for the absence of hepatotoxicity.

Drug Classes: Antiviral Agents

Other Drugs in the Class for Influenza: Amantadine, Baloxavir, Oseltamivir, Rimantadine, Zanamivir

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Peramivir – Rapivab®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Peramivir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Peramivir | 1041434-82-5 | C15-H28-N4-O4.3H2-O

## ANNOTATED BIBLIOGRAPHY

References updated: 22 June 2020

Zimmerman HJ. Antiviral agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 621-3. (Expert review of antiviral agents and liver injury published in 1999; amantadine and rimantadine have not caused "overt hepatic injury"; peramivir and other influenza neuraminidase inhibitors are not mentioned).
Núñez M. Influenza virus treatments. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 513. (Review of hepatotoxicity of antiviral agents; peramivir is not discussed).
Acosta EP. Antiviral agents (nonretroviral). In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1105-18. (Textbook of pharmacology and therapeutics).
Birnkrant D, Cox E. (2009). The Emergency Use Authorization of peramivir for treatment of 2009 H1N1 influenza. N Engl J Med. (Announcement of the FDA’s emergency use authorization of peramivir during the 2009 H1N1 epidemic of influenza A and the legal and scientific basis for the decision).
Kohno S, Kida H, Mizuguchi M, Shimada J. (2010). S-021812 Clinical Study Group. Efficacy and safety of intravenous peramivir for treatment of seasonal influenza virus infection. Antimicrob Agents Chemother. (Among 296 adults with acute influenza treated with a single intravenous infusion of peramivir [300 or 600 mg] vs placebo within 48 hours of clinical onset, symptoms and viral titers decreased faster with active treatment and adverse event rates were similar, ALT elevations occurring in 4% [300 mg], 7% [600 mg] and 8% [placebo] of subjects).
Yingying C. (2011). Abnormal liver chemistry in patients with influenza A H1N1. Liver Int. (Among 131 patients admitted to a hospital for influenza A H1N1, 13% had abnormal ALT and 5% abnormal Alk P elevations, but the range of values was not provided).
Kohno S, Kida H, Mizuguchi M, Hirotsu N, Ishida T, Kadota J, Shimada J. (2011). S-021812 Clinical Study Group. Intravenous peramivir for treatment of influenza A and B virus infection in high-risk patients. Antimicrob Agents Chemother. (Among 37 patients with acute influenza who were considered at high risk for complications who were treated with peramivir [300 or 600 mg] for 1-5 days, resolution of symptoms was faster with the higher dose and adverse events arose in 74% of patients; no mention of ALT elevations or hepatotoxicity).
Sorbello A, Jones SC, Carter W, Struble K, Boucher R, Truffa M, Birnkrant D, et al. (2012). Emergency use authorization for intravenous peramivir: evaluation of safety in the treatment of hospitalized patients infected with 2009 H1N1 influenza A virus. Clin Infect Dis. (Analysis of adverse event reports to the FDA from 344 patients with influenza who were treated with peramivir during the emergency use authorization period revealed 8 cases of hepatitis [ ALT elevations only] and 1 case of hepatic failure; however, no details were provided, and the authors concluded that the only adverse event reasonably attributable to peramivir was rash [4% of events]).
Sugaya N, Kohno S, Ishibashi T, Wajima T, Takahashi T. (2012). Efficacy, safety, and pharmacokinetics of intravenous peramivir in children with 2009 pandemic H1N1 influenza A virus infection. Antimicrob Agents Chemother. (Among 106 children with H1N1 influenza A treated within 2 days of onset with peramivir [10 mg/kg] once daily, 64% developed adverse events, most commonly diarrhea [16%] and vomiting [9%]; no mention of ALT elevations or hepatotoxicity).
Louie JK, Yang S, Yen C, Acosta M, Schechter R, Uyeki TM. (2012). Use of intravenous peramivir for treatment of severe influenza A(H1N1)pdm09. PLoS One. (During a 16 month period in 2009, 1962 California residents were hospitalized for influenza, of whom 57 were critically ill and were treated with intravenous peramivir starting 2-38 days after onset: 55 [96%] with pneumonia, 54 [95%] on mechanical ventilation of whom 29 [51%] died; no mention of ALT elevations or hepatotoxicity).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to a drug used to treat influenza).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 cases [1.3%] were attributed to antiviral agents, but none to antivirals used to treat influenza).
Komeda T, Ishii S, Itoh Y, Ariyasu Y, Sanekata M, Yoshikawa T, Shimada J. (2015). Post-marketing safety and effectiveness evaluation of the intravenous anti-influenza neuraminidase inhibitor peramivir. II: a pediatric drug use investigation. J Infect Chemother. (Among 1199 children with influenza treated with intravenous peramivir at 161 centers in Japan, there were 245 adverse events in 161 children [14%], most commonly diarrhea, abnormal behavior, with serious events in 23 children [2%], but no mention of ALT elevations or hepatotoxicity).
(2015). Peramivir (Rapivab): an IV neuraminidase inhibitor for treatment of influenza. Med Lett Drugs Ther. (Concise summary of the mechanism of action, clinical efficacy, safety and costs of peramivir shortly after its formal approval in the US; mentions side effects of gastrointestinal symptoms, behavioral disorders and rash [including rare cases of erythema multiforme and Stevens Johnson syndrome], but does not mention ALT elevations or hepatotoxicity).
Komeda T, Ishii S, Itoh Y, Sanekata M, Yoshikawa T, Shimada J. (2016). Post-marketing safety evaluation of the intravenous anti-influenza neuraminidase inhibitor peramivir: A drug-use investigation in patients with high risk factors. J Infect Chemother. (Among 770 Japanese patients with influenza at high risk for complications who were treated with peramivir, adverse events were reported in 219 [28%], including elevations of ALT in 29 [4%], but the liver test abnormalities were considered due to the influenza infection rather than peramivir and there was no mention of clinically apparent liver injury).
(2017). Antiviral drugs for seasonal influenza 2016-2017. Med Lett Drugs Ther. (Concise summary of safety and efficacy of medications for influenza appropriate for the 2016-17 season; mentions that adverse effects of peramivir include nausea, vomiting and headache; no mention of liver injury).
Nakamura S, Miyazaki T, Izumikawa K, Kakeya H, Saisho Y, Yanagihara K, Miyazaki Y, et al. (2017). Efficacy and safety of intravenous peramivir compared With oseltamivir in high-risk patients infected with influenza A and B viruses: a multicenter randomized controlled study. Open Forum Infect Dis. (Among 92 high risk Japanese adults with influenza who were treated with a single dose of intravenous peramivir [600 mg] or a 5 day course of oseltamivir [75 mg twice daily], clinical response rates were similar in the two groups but adverse events were less common with peramivir than oseltamivir [2% vs 13%], with “liver dysfunction” occurring in none vs 2 [4% ).
Choi WS, Ryu SY, Lee J, Hong SB, Eom JS, Shin J, Park KH, et al. (2018). Safety and effectiveness of peramivir in Korean adult influenza patients: prospective observational study based on post-marketing surveillance data. J Korean Med Sci. (Among 3024 Korean adults with influenza treated with intravenous peramivir in postmarketing surveillance studies, only 35 [1.2%] were reported as having an adverse event, which were mostly mild fevers, diarrhea and nausea, liver test abnormalities being reported in only 2 [<0.1%]).
(2019). Antiviral drugs for treatment and prophylaxis of seasonal influenza. Med Lett Drugs Ther. (Concise review of the drug therapy of influenza mentions that there are no data suggesting the superiority of one drug over another, they are all approved for treatment of uncomplicated influenza, should be started as soon as possible, and have been shown to shorten the duration of symptoms by one day in adults; no mention of ALT elevations or hepatotoxicity of any of the neuraminidase inhibitors).
(2020). Antiviral drugs for influenza. Med Lett Drugs Ther. (Concise review of the drug therapy of influenza mentions that there is no evidence that one drug is more effective than any other in treating uncomplicated influenza infections but that oseltamivir is preferred for treatment of pregnant women, hospitalized patients and those with severe, complicated or progressive illness; adverse events reported with peramivir include diarrhea and neutropenia; no mention of ALT elevations or hepatic adverse events).

## OTHER REFERENCE LINKS

1 Recent References on Peramivir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Peramivir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Peramivir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Peramivir)